# Carvedilol

## OVERVIEW

### Introduction

Carvedilol is a unique antihypertensive medication with activity against both alpha- and beta-adrenergic receptors. Carvedilol has been linked to at least one instance of clinically apparent liver injury.

### Background

Carvedilol (kar' ve dil" ol) is a unique beta-blocker and antihypertensive agent that has both alpha- and beta-adrenergic receptor blocking activity. The beta-blockade is nonselective, acting on both beta-1 and beta-2 adrenergic receptors. Beta-1 adrenergic blockade reduces the heart rate and myocardial contractility by slowing the AV conduction and suppressing automaticity. Beta-2 blockade affects peripheral vascular resistance and can cause bronchospasm and hypoglycemia. The alpha-adrenergic blockade acts on alpha-1 receptors which results in relaxation of arterial smooth muscle and vasodilation. Carvedilol was approved for use in the United States in 1995 and is still in wide use with more than 2.5 million prescriptions filled yearly. Current indications include hypertension and heart failure. Carvedilol is also approved for use after myocardial infarction to reduce cardiovascular mortality. Carvedilol is also used off label to treat migraine and vascular headaches. Carvedilol is available in tablets of 3.125, 6.25, 12.5 and 25 mg in generic forms and under the trade name Coreg. The typical initial oral dose in adults is 6.25 mg twice daily, with subsequent dose modification based upon clinical response and tolerance, the average total daily maintenance dose being 25 to 50 mg. Extended release capsules of 10, 20, 40 and 80 mg capsules which can be given once daily are also available. Common side effects of carvedilol include bradycardia, hypotension, fatigue, dizziness, depression, memory loss, impotence, cold limbs and less commonly severe hypotension, heart failure and bronchospasm. Sudden withdrawal can trigger rebound hypertension. Beta-blockers are contraindicated in patients with asthma, bradycardia and heart failure and should be used cautiously in the elderly and in patients with diabetes.

### Hepatotoxicity

Mild-to-moderate elevations in serum aminotransferase levels occur in less than 2% of patients on carvedilol and are usually transient and asymptomatic, resolving even with continuation of therapy. Despite its wide spread use, carvedilol has been linked to only a single case of clinically apparent liver injury, with injury arising 6 months after starting therapy and a mixed pattern of enzyme elevations without jaundice or signs of hypersensitivity or autoimmunity, and rapid recovery on stopping. Thus, clinically apparent liver injury from carvediol is exceeding rare.

Likelihood score: D (Possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Carvedilol undergoes extensive metabolism by the liver into both active and inactive metabolites and its excretion is largely biliary. The mechanism of liver injury due to carvedilol is unknown but is likely to be an idiosyncratic reaction to the drug or a metabolite.

References to the safety and potential hepatotoxicity of carvedilol are provided in the overview on Beta-Adrenergic Receptor Antagonists, last updated in June 2019.

Drug Class: Beta-Adrenergic Receptor Antagonists

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Carvedilol – Generic, Coreg®

DRUG CLASS

Beta-Adrenergic Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=carvedilol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Carvedilol | 72956-09-3 | C24-H26-N2-O4 | Carvedilol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Carvedilol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Carvedilol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Carvedilol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Carvedilol)